# Androgenic Steroids

## OVERVIEW

### Introduction

Androgenic steroids are used for male sex hormone replacement and in the therapy of malignancies. The androgens also have anabolic effects and are used in catabolic or muscle wasting states. In addition, the synthetic anabolic steroids are now widely used illicitly for exercise and athletic performance enhancement. Many synthetic androgenic steroids are capable of causing cholestatic liver injury and long term use of androgens is associated with development of liver tumors including hepatocellular carcinoma, hepatic adenoma and vascular changes (peliosis hepatis).

### Background

Testosterone is the major male sex hormone and is produced by the male testes in men and to a lesser extent by the adrenal glands in both men and women. Unmodified testosterone is not orally available, so it must be given intramuscularly, sublingually or by transcutaneous patch. Modifications of testosterone have been developed that are more bioavailable or have a longer duration of action. Modification by C-17β esterification (testosterone cypionate, enanthate and propionate) maintains the virilizing effects of testosterone, but increases potency and duration of action. Alkylation of the C-17α position of testosterone allows for oral administration by inhibiting metabolic deactivation in the liver and often alters the relative anabolic potency in relation to the masculinizing effects. The C-17 alkylated testosterones include methyltestosterone (meth" il tes tos' ter one), methandrostenolone (meth an" droe stene' oh lone), oxymetholone (ox" i meth' oh lone), danazol (dan' a zol), epistane (ep is tane’), fluoxymesterone (floo ox" i mes' ter one), stanozolol (stan oh' zoe lol), norethandrolone (nor eth' an droe lone), and oxandrolone (ox an' droe lone), and have been extensively evaluated as a means of increasing weight gain and muscle development in catabolic states as well as to improve athletic performance. They have also been used to treat aplastic anemia and bone marrow failure of several causes. They are often well tolerated and have limited virilizing activity. However, the C-17α alkylated androgenic steroids have all been implicated in cases of liver injury, including prolonged cholestasis, peliosis hepatis, nodular regeneration, hepatic adenomas and hepatocellular carcinoma. In contrast, the C-17β esterified testosterones have only rarely been implicated in causing cholestasis, although their long term use may increase the risk of hepatic tumors and nodular transformation, but seemingly at a much lower rate than the 17α alkylated testosterones. Currently approved uses of androgenic steroids include androgen deficiency, delayed puberty, breast cancer, postpartum breast engorgement, hereditary angioneurotic edema, endometriosis and fibrocystic breast disease. The androgenic steroids are also used off label and illegally as a means of increasing muscle mass and athletic performance. The abuse of anabolic steroids is particularly common among body builders and young male athletes, although their use has been banned from the Olympics and in major professional and college sports. Recently, anabolic steroids have been found in some nutritional supplements available over-the-counter or via the internet which are advertised as increasing a sense of wellbeing and muscle mass or as an aid to body building.

### Hepatotoxicity

Androgenic and anabolic steroids have been implicated in four distinct forms of liver injury: transient serum enzyme elevations, an acute cholestatic syndrome (“bland cholestasis”), chronic vascular injury to the liver (peliosis hepatis) and hepatic tumors including adenomas and hepatocellular carcinoma. These adverse events have been most closely linked with the C-17α alkylated testosterones, although tumors have also been associated with unmodified and esterified testosterone preparations.

Use of androgenic steroids is associated with a variable rate of serum enzyme elevations which are usually asymptomatic and self-limited. Such elevations have been most closely linked to danazol and oxymetholone, but are usually transient and do not require dose adjustment or discontinuation.

More importantly, therapy with anabolic steroids is linked to a distinctive form of acute cholestasis often referred to as “bland cholestasis”. The liver injury generally arises within 1 to 4 months of starting therapy, but may be delayed to as long as 6 to 24 months (Case 1). The onset is usually insidious with development of nausea, fatigue and itching followed by dark urine and jaundice. Jaundice and pruritus can be prolonged even if the anabolic steroids are discontinued promptly. Typically, serum enzyme elevations are quite modest, with ALT and alkaline phosphatase levels that are less than 2 to 3 times elevated and that are sometimes normal despite deep jaundice. Serum ALT levels may be somewhat high early during injury, but then fall to moderate or low levels. Liver biopsy typically shows a bland cholestasis with minimal inflammation and hepatocellular necrosis. Bile duct injury is typically absent or mild and vanishing bile duct syndrome rarely ensues. The frequency of acute cholestasis from androgenic steroids is not well known, but it is likely somewhat dose related and may occur in ~1% of patients treated with methyltestosterone, danazol, stanozolol or oxymetholone. Cholestasis has not been described in patients receiving unmodified testosterone (by injection or transdermal patch). This clinical phenotype of bland cholestasis is so typical of anabolic steroids, that the diagnosis can be suspected in a patient who denies taking anabolic steroids or who is taking an herbal formulation meant to increase muscle strength or energy and that contains an anabolic steroid even though it is not labelled as such.

Use of anabolic steroids has also been linked to vascular changes in the liver referred to as peliosis hepatis. Peliosis hepatis is a rare syndrome in which there are blood filled enlarged sinusoids and cysts focally or throughout the liver. There is usually an accompanying sinusoidal dilatation and loss of the normal endothelial barrier. The liver may be enlarged, deep red in color and fragile. Peliosis hepatis most typically occurs in patients with advanced wasting diseases (tuberculosis, cancer), but has also been associated with long term use of anabolic steroid therapy for aplastic anemia and hypogonadism as well as in body building. Serum enzyme levels are usually normal or are mildly and nonspecifically elevated. Patients may present with right upper quadrant discomfort and hepatomegaly or with sudden abdominal pain and vascular collapse due to hepatic rupture and hemoperitoneum. Peliosis may also be an incidental finding found on imaging of the liver or during abdominal surgery or at autopsy. Peliosis associated with anabolic steroids usually reverses, at least in part, with stopping therapy. Peliosis can involve other organs, most typically the spleen.

The most serious complication of anabolic steroid use is the development of hepatic tumors, either adenoma or hepatocellular carcinoma. The hepatic tumors arise in patients on long term androgenic steroids, usually during therapy of aplastic anemia or hypogonadism, but occasionally in athletes or body builders using anabolic steroids illicitly. Tumors are typically found after 5 to 15 years of use, but onset within 2 years of starting therapy with testosterone esters has been described. Many of the case reports have occurred in patients with other risk factors for cancer, such as Fanconi’s syndrome, iron overload or chronic hepatitis C (from blood transfusions). However, hepatic adenomas and hepatocellular carcinoma have also been described in patients taking androgenic steroids who have no other evidence of liver disease and normal histology in the nontumorous parts of the liver. The pathology of the tumors is usually hepatic adenoma or “well differentiated” hepatocellular carcinoma or hepatic adenoma with areas of malignant transformation. Rare instances of cholangiocarcinoma and angiosarcoma have also been described in patients on long term androgenic steroids. Clinical presentation is generally with right upper quadrant discomfort and a hepatic mass found clinically or on imaging studies. Routine liver tests are often normal unless there is extensive spread or rupture or an accompanying liver disease. Alpha-fetoprotein levels are usually normal. There is often (but not always) spontaneous regression in the tumor when the anabolic steroids are stopped. Hepatocellular carcinoma arising during anabolic steroid therapy is believed to have a better prognosis than that related to cirrhosis or chronic hepatitis B and C; however, deaths from hepatic rupture or tumor spread and metastasis have been reported in patients with anabolic steroid related hepatocellular carcinoma without cirrhosis.

Finally, nodular regenerative hyperplasia of the liver has been described in rare patients on long term anabolic or androgenic steroids. The condition is usually asymptomatic or associated with mild abdominal discomfort due to hepatomegaly. Rarely, marked nodular regenerative hyperplasia with portal hypertension and splenomegaly has been described. This process may also be related with development of hepatic tumors with androgenic steroids as nodular regeneration is sometimes found in the surrounding “normal” liver.

### Mechanism of Injury

The androgens act by engagement of intracellular androgenic steroid receptors which are translocated to the nucleus and bind to androgen response elements on DNA inducing a cassette of androgen stimulated genes that are important in cell growth and development. An unregulated growth stimulus to hepatocytes is the likely cause of nodular regeneration and hepatic tumors related to anabolic steroid use. The cause of cholestasis due to the C-17 substituted androgens is not well defined, but high doses cause a similar cholestasis in some animal models. The syndrome is similar to cholestasis of pregnancy and the jaundice associated with high doses of estrogens or birth control pills and may be due to partial lack or variant of bile salt transporter proteins, as reported in some patients with androgenic anabolic steroid associated cholestasis.

### Outcome and Management

The severity of liver injury due to anabolic steroids ranges from minor, transient serum enzyme elevations to profound and prolonged cholestasis, as well as hepatic peliosis and benign and malignant liver tumors. The first priority in management should be stopping the androgenic steroid. Unfortunately, athletes and body builders may resist this recommendation. Merely decreasing the dose of androgenic steroid or switching to another formulation is not appropriate and should be specifically discouraged. Patients being treated for hypogonadism may be switched to an unmodified form of testosterone, given by injection or cutaneous patch. Patients with marked cholestasis may be benefitted by symptomatic therapy of pruritus and fat soluble vitamin supplementation. Ursodiol is often used in drug induced cholestasis, but is efficacy has never been shown in a controlled prospective manner. Use of corticosteroids is usually ineffective and should be avoided. The syndrome is usually reversable with stopping therapy, but full recovery is often delayed. In addition, fatalities have been reported, usually due to marked cholestasis complicated by malnutrition, renal failure and associated opportunistic infections.

Representative androgenic steroids include the following: danazol, fluoxymesterone, methandienone, methenolone, methyltestosterone, nandrolone, norethandrolone, oxandrolone, oxymetholone, stanozolol, testosterone (cypionate, enanthate, propionate).

Drug Class: Androgenic Steroids

## CASE REPORTS

### Case 1. Cholestasis due to anabolic steroid use.(1)

A 24 year old body builder developed pruritus and jaundice having taken various anabolic steroids for one and a half years. He was also taking several herbal products and dietary supplements including Ma Huang (6% ephedrine), carnitine and chromium. He also drank alcohol, estimating his average intake as one case of beer per day for the last year. He developed dark urine and jaundice and stopped all medications and his alcohol intake promptly. Despite this, he remained jaundiced for a month and had worsening nausea and weight loss and eventually sought medical care. He had no history of liver disease or risk factors for viral hepatitis and took no other medications. On examination, he was muscular and physically fit but deeply jaundiced. He had an enlarged liver but no rash, fever or splenomegaly. Laboratory testing showed a total serum bilirubin of 53 mg/dL, but only modest elevations in serum aminotransferase and a normal alkaline phosphatase level (Table). His prothrombin time was normal. Tests for hepatitis A, B and C were negative. Abdominal ultrasound showed no evidence of biliary obstruction. Liver biopsy was not done. He was treated symptomatically for pruritus with antihistamines, cholestyramine and ursodiol. His jaundice gradually improved and pruritus waned. Six months after the onset of jaundice, he was asymptomatic, had regained most of his weight loss (40 pounds), serum bilirubin was 1.5 mg/dL and serum enzymes were normal.

#### Key Points

Medication: | Anabolic steroids (nandrolone, stanozolol)
Pattern: | Bland cholestasis
Severity: | 3+ (jaundice, hospitalization)
Latency: | 16 months
Recovery: | 0.6 months
Other medications: | Various herbal products and dietary supplements

#### Laboratory Values

Time After Stopping | ALT (U/L) | Alk P (U/L) | | Bilirubin (mg/L) | Comments
Anabolic agent use for ~1.5 years
6 weeks | 237 | 129 | 21
8 weeks | 90 | 121 | 53
10 weeks | 203 | 91 | 51 | | Ursodiol started
12 weeks | 119 | 81 | 22
14 weeks | 116 | 67 | 8
4 months | 58 | 50 | 4
5 months | 33 | 75 | 1.5 | | Asymptomatic
Normal Values | <56 | <139 | <1.2

#### Comment

A very typical case of severe cholestasis due to anabolic steroid use. Because the steroids were being used without medical supervision, the dose and actual duration of use of each preparation was unclear, but cholestasis usually arises within 4 to 12 weeks of starting a C-17 alkylated androgenic steroid. The jaundice can be severe and prolonged and accompanied by severe pruritus and marked weight loss. The serum enzymes are typically minimally elevated except for a short period immediately after stopping therapy. The pattern of enzyme elevations can be hepatocellular, cholestatic or mixed. Liver biopsy reveals a “bland” cholestasis with minimal inflammation and hepatocellular necrosis. Ma Huang has also been implicated in cases of drug induced liver injury, but is associated with an acute hepatocellular pattern of injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Danazol – Generic,

Fluoxymesterone – Androxy®,

Methandienone – Dianabol®

Methenolone – Primobolan®, Nibal®

Methyltestosterone – Generic, Android®, Methitest®, Testred®

Nandrolone – Generic, Deca-Durabolin®

Norethandrolone – Generic, Nilevar®, Pribabol®

Oxandrolone – Generic, Oxandrin®

Oxymetholone – Anadrol®

Stanozolol – Winstrol®

Testosterone – Generic, Depo-Testosterone®

DRUG CLASS

Androgenic Steroids

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

Danazol (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=DANAZOL&pagesize=20&page=1), Fluoxymesterone (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=FLUOXYMESTERONE&pagesize=20&page=1), Methandienone, Methenolone, Methyltestosterone (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=METHYLTESTOSTERONE&pagesize=20&page=1), Nandrolone (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=a586b484-1b46-40b9-9508-fd28002ad383), Norethandrolone, Oxandrolone (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=OXANDROLONE&pagesize=20&page=1), Oxymetholone (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=4b9c6c34-9cb2-4d70-b70e-c7ce2fda4212), Stanozolol, Testosterone (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=TESTOSTERONE&pagesize=20&page=1)

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Danazol | 17230-88-5 | C22-H27-N-O2
Fluoxymesterone | 76-43-7 | C20-H29-F-O3
Methandienone | 72-63-9 | C20-H28-O2
Methenolone | 303-42-4 | C27-H42-O3
Methyltestosterone | 58-18-4 | C20-H30-O2
Nandrolone | 360-70-3 | C28-H44-O3
Norethandrolone | 52-78-8 | C20-H30-O2
Oxandrolone | 53-39-4 | C19-H30-O3
Oxymetholone | 434-07-1 | C21-H32-O3
Stanozolol | 10418-03-8 | C21-H32-N2-O
Testosterone | 58-20-8 | C27-H40-O3

## CITED REFERENCE

1 Singh C, Bishop P, Wilson R. (1996). Extreme hyperbilirubinemia associated with the use of anabolic steroids, health/nutritional supplements and ethanol: response to ursodeoxycholic acid treatment. Am J Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 30 May 2020

Abbreviations: HDS, herbal and dietary supplements; BSP, bromosulfophthalein.

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 555-88. (Expert review of effects of androgenic steroids on the liver published in 1999; two forms of hepatic injury occur with anabolic steroids: cholestasis that occurs within the first 6 months associated with the synthetic agents that have an alkyl group in the C17 position, and a delayed injury with vascular or neoplastic changes in which natural androgens can play a role).
Chitturi S, Farrell GC. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 605-20. (Review of hepatotoxicity of androgenic steroids including cholestasis, vascular disorders, benign tumors and hepatocellular carcinoma).
Synder P. Androgens and the male reproductive tract. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 833-43. (Textbook of pharmacology and therapeutics).
Werner SC, Hanger FM, Kritzler RA. (1950). Jaundice during methyltestosterone therapy. Am J Med. (7 patients: 6 men and 1 woman who developed jaundice during oral methyltestosterone therapy, ages 17-67 years, onset after 8 days to 4 months, prodrome of nausea and malaise for 1-2 weeks before jaundice [peak bilirubin 5.1-29 mg/dL, Alk P 1.4 to 4.5 times ULN, albumin normal], lasted 1-3 months; biopsy showed bile stasis with little inflammation; recovery complete; no recurrence upon rechallenge in 3 patients).
Brick IB, Kyle LH. (1952). Jaundice of hepatic origin during the course of methyltestosterone therapy. N Engl J Med. (Two men, ages 44 and 63 years, developed jaundice 7 and 12 weeks after switching from long term testosterone injections to sublingual methyltestosterone [bilirubin not given and 6.8 mg/dL, Alk P 4-5 times ULN], with full but slow recovery after stopping).
Burger RA, Marcuse PM. (1952). Peliosis hepatis: report of a case. Am J Clin Pathol. (39 year old woman with metastatic colon cancer and emaciation treated with oral testosterone was found to have peliosis hepatis on autopsy, without endothelial lining and with hepatic necrosis).
Lloyd-Thomas HG, Sherlock S. (1952). Testosterone therapy for the pruritus of obstructive jaundice. Br Med J. (Experience in treating 7 patients having intractable itching due to liver disease with methyltestosterone, which led to improvement in itching within 4-7 days but worsening jaundice, serum bilirubin rising by 2.0-9.3 mg/dL).
Almaden PJ, Ross SW. (1954). Jaundice due to methyl testosterone therapy. Ann Intern Med. (45 year old woman developed jaundice 7 months after starting methyltestosterone [bilirubin 16.7 mg/dL Alk P slightly elevated], biopsy showing intrahepatic cholestasis and resolution of jaundice within 2 months of stopping).
Kaplan AA. (1956). Jaundice due to methyltestosterone therapy. Gastroenterology. (58 year old man developed jaundice and pruritus 6 months after starting sublingual methyltestosterone [bilirubin 13.6 mg/dL, Alk P rising to twice normal], resolving 3 months after stopping).
Koszalka MF. (1957). Medical obstructive jaundice: report of a death due to methyltestosterone. J Lancet. (60 year old man with colon cancer developed jaundice 3 weeks after starting methyltestosterone which was continued another 3 weeks [bilirubin 10 mg/dL, Alk P rising to twice normal], with progressive jaundice and death from hepatic failure 2 months after presentation, autopsy showing intrahepatic cholestasis).
Peters JH, Randall AH, Mendeloff J, Peace R, Coberly JC, Hurley MB. (1958). Jaundice during administration of methylestrenolone. J Clin Endocrinol Metab. (Two of 10 patients receiving 17-methyl-19-nortestosterone for cancer developed jaundice after 4 and 6 weeks of therapy; both died of underlying cancer while still jaundiced).
Seelen JC. (1958). Complications during administration of methylestrenolone. J Clin Endocrinol Metab. (Pregnant woman treated with methylestrenolone for habitual abortion developed jaundice 2 months later [bilirubin 19 mg/dL, Alk P 1.5 times ULN], resolving after stopping therapy).
Kory RC, Bradley MH, Watson RN, Callahan R, Peters BJ. (1959). A six-month evaluation of an anabolic drug, norethandrolone, in underweight persons. II. Bromsulphalein (BSP) retention and liver function. Am J Med. (Prolonged BSP retention found in 74% of samples from 47 patients on norethandrolone for weight gain, returned to normal within a few weeks of stopping; only two patients had mild bilirubin elevations [1.7 and 2.2 mg/dL]).
Schaffner F, Popper H, Chesrow E. (1959). Cholestasis produced by administration of norethandrolone. Am J Med. (Among 27 patients treated with norethandrolone for nutritional support for 3-5 weeks undergoing liver biopsy before and during therapy, 4 developed cholestasis within 1-5 weeks [bilirubin 32, 1.8, 1.0 and 0.7 mg/dL, AST 190-224 U/L, Alk P 2-20 times ULN], all resolving after stopping).
Foss GL, Simpson SL. (1959). Oral methyltestosterone and jaundice. Br Med J. (Despite extensive use of methyltestosterone, authors found only one case of jaundice, 60 year old man developed jaundice after 5 weeks of therapy and subsequently died of dehydration and acidosis; summarizes 42 cases from literature; of 5 patients retreated, only one had recurrence).
Shaw RK, Gold GL. (1960). Jaundice associated with norethandrolone(Nilevar) therapy. Ann Intern Med. (60 year old with multiple myeloma developed pruritus after 12 weeks and jaundice after 16 weeks of norethandrolone [bilirubin 9.5 mg/dL, AST 25 U/L, Alk P 3 times ULN], biopsy showed intrahepatic cholestasis, resolving on stopping and prednisone therapy).
Wernze H. (1960). Dtsch med Wschr. (Study of BSP retention in 36 volunteers given C-17 alkylated androgenic steroids; retention rose from <5% to 6-23% within 8-30 days and fell to normal or near normal with 8-10 days thereafter, whereas AST, Alk P and bilirubin levels changed minimally if at all).
Kintzen W, Silny J. (1960). Peliosis hepatic after administration of fluoxymesterone. Can Med Assoc J. (60 year old woman with metastatic breast cancer treated with fluoxymesterone for 2 years was found to have peliosis hepatis on autopsy after death from widespread metastatic disease).
Schaffner F, Popper H, Perez V. (1960). Changes in bile canaliculi produced by norethandrolone: electron microscopic study of human and rat liver. J Lab Clin Med. (4 patients treated with norethandrolone for 2 weeks underwent liver biopsy which showed “mild nonspecific changes” by light microscopy, but dilated bile canaliculi and shortening of microvilli by electron microscopy).
Marquardt GH, Fisher CI, Levy P, Dowben RM. (1961). Effects of anabolic steroids on liver function tests and creatine excretion. JAMA. (Six anabolic steroids given to 38 healthy controls for 5 weeks; all led to increase in BSP retention [2.3-17.6%], but no change in bilirubin levels).
Wynn V, Landon J, Kawarau E. (1961). Studies of hepatic function during methandienone therapy. Lancet. (Followed liver tests in 30 patients treated with methandienone; AST elevations occurred in 27% [60-180 U/L], Alk P [2 times ULN] and bilirubin [2.0] in 1, and BSP retention in 62%; all without symptoms and resolving rapidly, some without stopping drug).
Perez-Mera RA, Shields CE. (1962). Jaundice associated with norethindrone acetate therapy. N Engl J Med. (35 year old woman developed jaundice and abdominal pain 2 years after starting norethindrone for dysmenorrhea [bilirubin 6.5 mg/dL], biopsy showing intrahepatic cholestasis and repeat biopsy 2 months after stopping estrogen showing resolution).
Wilder EM. (1962). Death due to liver failure following the use of methandrostenolone. Can Med Assoc J. (71 year old woman developed jaundice 8 weeks after starting methandrostenolone for osteoporosis [bilirubin 20.4 mg/dL, AST 200 U/L, Alk P twice normal], with progressive mental obtundation, coagulopathy and death 2 months later, autopsy showing shrunken liver with marked cholestasis).
Scherb J, Kirschner M, Arias IM. (1963). Studies of hepatic excretory function. The effect of 17α-ethyl-19-nortestosterone on sulfobromophthalein sodium (BSP) metabolism in man. J Clin Invest. (Prospective study of BSP metabolism in 8 subjects treated with 19-nortestosterone and 10 controls; BSP transport maximum decreased within 7-10 days of starting androgen therapy and returned to normal 1 week afterwards, BSP storage was normal; best explained as a decrease in excretion of conjugated BSP [similar to defect in Dubin-Johnson syndrome).
Gilbert EF, DaSilva AQ, Queen DM. (1963). Intrahepatic cholestasis with fatal termination following norethandrolone therapy. JAMA. (74 year old man developed jaundice 5 months after starting norethandrolone but continued for another month and developed delirium [bilirubin 20 mg/dL, AST 475 U/L, Alk P 3 times ULN], dying in hepatic coma; severe cholestasis on autopsy).
Marquardt GH, Logan CE, Tomhave WG, Dowben RM. (1964). Failure of non-17-alkylated anabolic steroids to produce abnormal liver function tests. J Clin Endocrinol Metab. (Prospective study of 23 patients given methenolone [non-C-17 substituted synthetic androgen] for weight gain found no change in BSP retention or serum bilirubin levels).
Yanoff M, Rawson AJ. (1964). Peliosis hepatis: an anatomic study with demonstration of two varieties. Arch Pathol. (Two cases: 73 year old woman with septic arthritis treated with norethandrolone for 6 weeks and 42 year old man with malignant teratoma treated with chemotherapy for 8 months, both found to have peliosis on autopsy; two forms of peliosis, one with and one without endothelial lining, anabolic steroids associated with the latter parenchymal type that also shows bile retention and hepatocyte necrosis).
DeLorimier AA, Gordan GS, Lowe RC, Carbone JV. (1965). Methyltestosterone, related steroids, and liver function. Arch Intern Med. (66 healthy controls were given 9 different 17α-alkylated androgenic steroids or testosterone for 2 weeks; no change in serum bilirubin or Alk P, but most resulted in increased BSP retention, not occurring with non-alkylated testosterone).
Ticktin HE, Zimmerman HJ. (1966). Effects of synthetic anabolic agent on hepatic function. Am J Med Sci. (Prospective analysis of liver tests in 54 patients treated with norbolethone for at least 2 weeks; reversible minor AST elevations in 33% and BSP retention in 66% [both dose related], bilirubin >1.0 mg/dL in 10% and abnormal Alk P in none).
Orlandi F, Jezequel AM. (1966). On the pathogenesis of the cholestasis induced by C-17 alkylated steroids: ultrastructure and functional changes of the liver cells during treatment. Rev Int Hepatol.
Glober GA, Wilkerson JA. (1968). Biliary cirrhosis following the administration of methyltestosterone. JAMA. (56 year old woman developed jaundice after taking a nutritional supplement with methyltestosterone and estrone for 4 years with prolonged jaundice [bilirubin 3.2 mg/dL, AST 7 UL, Alk P 54 KA U], evolving into cirrhosis over next 5 years with intractable pruritus and xanthomas; probable primary biliary cirrhosis).
(1969). Androgens and anabolic steroids. Br Med J. (Review of clinical indications, efficacy and safety of androgenic steroids; mentions that 17α-alkylated androgens can cause jaundice).
McGiven AR. (1970). Peliosis hepatis: case report and review of pathogenesis. J Pathol. (75 year old man with rheumatoid arthritis died of an acute myocardial infarction and was found to have peliosis hepatis on autopsy, having received methandienone for the previous year).
Rozman C, Urbano A, Galera H. (1971). Minerva Med.
Sansoy OM, Roy AN, Shields LM. (1971). Anabolic action and side effects of oxandrolone in 34 mental patients. Geriatrics. (34 patients were treated with oxandrolone for 2 months to promote weight gain after illness; AST levels increased and were abnormal in 53%, BSP increased in 35%; no patient developed jaundice).
Bernstein MS, Hunter RL, Yachnin S. (1971). Hepatoma and peliosis hepatis developing in a patient with Fanconi's anemia. N Engl J Med. (20 year old with Fanconi anemia developed HCC 1 year after starting oxymetholone with peliosis and multiple intrahepatic hematomas found on autopsy).
Johnson FL, Feagler JR, Lerner KG, Majerus PW, Siegel M, Hartmann JR, Thomas ED. (1972). Association of androgenic-anabolic steroid therapy with the development of hepatocellular carcinoma. Lancet. (Description of 4 cases of hepatocellular carcinoma related to C17-alkylated anabolic steroids given for aplastic anemia or Fanconi syndrome, ages 5-27 years taking drugs for 1-7 years; regression of tumor in one with withdrawal; all died within one year).
Guy JT, Auslander MO. (1973). Androgenic steroids and hepatocellular carcinoma. Lancet. (38 year old man with Fanconi’s syndrome had hepatocellular carcinoma on autopsy with mildly abnormal liver tests; had received androgenic steroids for 4 months at age 14).
Henderson JT, Richmond J, Sumerling MD. (1973). Androgenic-anabolic steroid therapy and hepatocellular cancer. Lancet. (12 year old male with aplastic anemia developed hepatocellular carcinoma having received 8 years of intermittent anabolic steroid therapy and many transfusions).
(1973). Liver tumours and steroid hormones. Lancet. (Editorial discussing the development of cholestasis, peliosis, adenoma and hepatocellular carcinoma after anabolic and contraceptive steroids).
Jackson ST, Rallison ML, Buntin WH, Johnson SB, Flynn RR. (1973). Use of oxandrolone for growth stimulation in children. Am J Dis Child. (9 children with constitutional growth retardation treated with oxandrolone for 2 6-month periods with careful monitoring; no clinical or laboratory evidence of liver injury; one patient had increase in BSP retention).
Presant CA, Safdar SH. (1973). Oxymetholone in myelofibrosis and chronic lymphocytic leukemia. Arch Intern Med. (Among 9 patients with refractory anemia, oxymetholone decreased transfusion requirements; 4 developed hepatotoxicity after 3-6 months, mild jaundice in 1 [bilirubin 3.1 mg/dL], mild Alk P or AST elevations in others, most resolved despite continuing medication).
Ziegenfuss J, Carabasi R. (1973). Androgens and hepatocellular carcinoma. Lancet. (68 year old man treated with methyltestosterone for 30 years for impotence presented with abdominal pain and hepatocellular carcinoma which was “almost completely” resected).
Frasier SD. (1973). Androgens and athletes. Am J Dis Child. (Editorial criticizing use of anabolic steroids to improve athletic performance).
Naeim F, Copper PH, Seminion AA. (1973). Peliosis hepatis: possible etiologic role of anabolic steroids. Arch Pathol. (Two cases of peliosis found on autopsy; a child with Fanconi’s anemia who had developed jaundice after a short course of fluoxymesterone; a 65 year old woman on hormone replacement therapy for 18 months who died of congestive heart failure).
Bagheri SA, Boyer JL. (1974). Peliosis hepatis associated with androgenic-anabolic steroid therapy. A severe form of hepatic injury. Ann Intern Med. (Seven patients on anabolic steroids for 2 to 27 months developed peliosis, 2 developing hemorrhage, 3 hepatic failure and 2 renal failure; serum bilirubin levels as high as 34.6 mg/dL, Alk P 1-20 times elevated, AST 30 to 950 U/L).
Groos G, Arnold OH, Brittinger G. (1974). Letter: Peliosis hepatis after long-term administration of oxymetholone. Lancet. (33 year old woman with aplastic anemia developed hepatomegaly [bilirubin 6.6 mg//dL, ALT 243 U/L, Alk P 229 U/L] 1.5 years after starting oxymetholone, liver size decreasing when drug was stopped).
Cattan D, Vesin P, Wautier J, Kalifat R, Meignan S. (1974). Liver tumors and steroid hormones. Lancet. (7 year old girl with Fanconi’s anemia developed hepatocellular carcinoma but had never received androgenic steroids, instead had transfusion-attributed hemosiderosis and cirrhosis).
Meadows AT, Naiman JL, Valdes-Dapena MV. (1974). Hepatoma associated with androgen therapy for aplastic anemia. J Pediatr. (6 year old girl with aplastic anemia on androgens for 3.5 years died of intracranial hemorrhage and was found to have hepatocellular carcinoma on autopsy; the liver was enlarged but liver tests were all normal).
Mulvihill JJ, Ridolfi RL, Schultz FR, Borzy MS, Haughton PB. (1975). Hepatic adenoma in Fanconi anemia treated with oxymetholone. J Pediatr. (12 year old boy with Fanconi’s anemia treated with oxymetholone developed jaundice [bilirubin 23 mg/dL and “liver function abnormalities”], improving when oxymetholone was stopped; on autopsy after intracerebral bleed found to have 9 cm hepatic adenoma “with distant metastases”).
Sarna G, Tomasulo P, Lotz MJ, Bubinak JF, Shulman NR. (1975). Multiple neoplasms in two siblings with a variant form of Fanconi's anemia. Cancer. (Two brothers with Fanconi’s anemia on long term androgen therapy both developed malignancies, including leukemia, gingival squamous cell cancer, and hepatocellular carcinoma).
Kühböck J, Radaszkiewicz T, Walek H. (1975). Med Klin.
Ball JH, Lowrie EG, Hampers CL, Merrill JP. (1975). Testosterone therapy in hemodialysis patients. Clin Nephrol. (30 patients on chronic hemodialysis were treated with testosterone injections for anemia; AST elevations occurred in both treated and untreated controls).
Farrell GC, Joshua DE, Uren RF, Baird PJ, Perkins KW, Kronenberg H. (1975). Androgen-induced hepatoma. Lancet. (Three cases of hepatocellular carcinoma in men on androgenic steroids, ages 28 to 40 years, on oxymetholone or methyltestosterone for 5-8 years, liver and tumor size decreasing on stopping androgenic steroids).
Anthony PP. (1975). Hepatoma associated with androgenic steroids. Lancet. (Letter in response to Farrell [1975] stressing the poor prognosis of hepatocellular carcinoma; median survival time being 1 month and raising a question of the accuracy of the diagnosis).
Bakker K, Brouwers TM, Houthoff HJ, Postma A. (1976). Ned Tijdschr Geneeskd.
Kew MC, Van Coller B, Prowse CM, Skikne B, Wolfsdorf JI, Isdale J, Krawitz S, et al. (1976). Occurrence of primary hepatocellular cancer and peliosis hepatis after treatment with androgenic steroids. S Afr Med J. (3 cases of complications of androgenic steroids: 34 year old woman with Fanconi’s anemia developed hepatocellular carcinoma after 7 years of therapy with methyltestosterone and 2 children [1 girl and 1 boy] developed peliosis hepatis, 5 and 8 years after starting androgenic steroids, both died soon after diagnosis).
Kessler E, Bar-Meir S, Pinkhas J. (1976). Harefuah.
Boyer JL, Preisig R, Zbinden G, de Kretser DM, Wang C, Paulsen CA. (1976). Guidelines for assessment of potential hepatotoxic effects of synthetic androgens, anabolic agents and progestogens in their use in males as antifertility agents. Contraception. (Recommendations for monitoring for hepatotoxicity in trials of anabolic steroids).
Hast R, Skårberg KO, Engstedt L, Jameson S, Killander A, Lundh B, Reizenstein P, et al. (1976). Oxymetholone treatment in aregenerative anaemia. II. Remission and survival—a prospective study. Scand J Haematol. (53 patients with anemia due to bone marrow insufficiency were treated with oxymetholone for at least 6 months; 3 developed jaundice requiring discontinuation).
Hervey GR, Hutchinson I, Knibbs AV, Burkinshaw L, Jones PR, Norgan NG, Levell MJ. (1976). "Anabolic" effects of methandienone in men undergoing athletic training. Lancet. (Double-blind crossover study of 6 weeks of methandienone in 11 male athletes; no change in bilirubin, ALT, AST or Alk P levels during drug period).
Lesna M, Spencer I, Walker W. (1976). Liver nodules and androgens. Lancet. (17 year old male with long standing aplastic anemia treated with oxymetholone developed sudden rupture of right lobe of liver and autopsy revealed multiple hepatic nodules and adenomas).
Slater SD, Davidson JF, Patrick RS. (1976). Jaundice induced by stanozolol hypersensitivity. Postgrad Med J. (66 year old man developed jaundice 7 months after starting stanozolol [bilirubin 8.0 mg/dL, ALT 74 U/L, Alk P 3 times ULN], with biopsy showing cholestasis but conspicuous eosinophils suggesting “hypersensitivity” with slow resolution over ensuing 6 months).
Sweeney EC, Evans DJ. (1976). Hepatic lesions in patients treated with synthetic anabolic steroids. J Clin Pathol. (Three cases of liver injury due to anabolic steroids; 8 year old boy with Fanconi’s syndrome developed hepatocellular carcinoma after 3 years of methyltestosterone therapy; 46 year old man with severe, ultimately fatal cholestasis [bilirubin 9.8 mg/dL, AST 102 U/L, Alk P 1510 U/L] 3 months after starting oxymetholone; 31 year old woman with aplastic anemia died of intracerebral bleeding after 3 months of oxymetholone therapy and had regenerative hepatic nodules on autopsy).
Tso SC, Chan TK, Todd D. (1977). Aplastic anaemia: a study of prognosis and the effect of androgen therapy. Q J Med. (129 cases of aplastic anemia from Hong Kong between 1955-74; 75 received androgen therapy, among whom 12 [16%] had ALT elevations, 7 [10%] jaundice and 2 died with persistent jaundice).
Young GP, Bhathal PS, Sullivan JR, Wall AJ, Fone DJ, Hurley TH. (1977). Fatal hepatic coma complicating oxymetholone therapy in multiple myeloma. Aust N Z J Med. (Two patients, 56 year old woman and 60 year old man developed severe jaundice 6 and 8 weeks after starting oxymetholone for multiple myeloma [bilirubin 11.7 and 21.9 mg/dL, AST normal, Alk P 286 and 700 U/L], with progressive jaundice, renal failure, hepatic encephalopathy and death within 4-6 weeks of presentation).
Leong AS, Sage RE. (1977). Drug-induced hepatic injury. Aust N Z J Med. (Letter in response to Young [1977] describing 76 year old woman who developed jaundice while receiving oxymetholone and was continued for 3 months [bilirubin 6.2 mg/dL, ALT 346 U/L, Alk P 116 U/L], followed by hepatic failure but biopsy showed marked cholestasis with little necrosis).
Bhathal PS, Fone DJ, Hurley TH, Sullivan JR, Wall AJ, Young GP. (1977). Drug-induced hepatic injury. Aust N Z J Med. (Reply to Leong and Sage [1977]; retrospective review of 27 patients with multiple myeloma treated with oxymetholone identified 9 [47%] who developed jaundice).
Nadell J, Kosek J. (1977). Peliosis hepatis. Twelve cases associated with oral androgen therapy. Arch Pathol Lab Med. (12 patients with peliosis who had received oral androgens for 3 to 24 months from a single institution; 3 died of hepatic failure related to peliosis, one had diagnosis by biopsy and peliosis resolved with stopping androgens, 8 others found incidentally on autopsy; also reviewed 42 cases of peliosis in English literature).
Bird DR, Vowles KDJ. (1977). Liver damage from long-term methyltestosterone. Lancet. (39 year old transsexual treated with methyltestosterone for 7 years developed sudden hepatic rupture due to peliosis hepatis).
Westaby D, Ogle SJ, Paradinas FJ, Randell JB, Murray-Lyon IM. (1977). Liver damage from long-term methyltestosterone. Lancet. (Among 60 patients on long term methyltestosterone, 32% had raised AST, 55% abnormal liver scan; liver biopsies in 11 showed sinusoidal dilatation in 9 and cholestasis in 3 [one with bilirubin of 1.7 mg/dL] and one developed adenoma).
Mokrohisky ST, Ambruso DR, Hathaway WE. (1977). Fulminant hepatic neoplasia after androgen therapy. N Engl J Med. (6 year old girl with Fanconi’s anemia developed hepatomegaly 2 months after starting oxymetholone with hepatocellular carcinoma in a noncirrhotic liver, dying 5 weeks after diagnosis).
Boyd PR, Mark GJ. (1977). Multiple hepatic adenomas and a hepatocellular carcinoma in a man on oral methyl testosterone for 11 years. Cancer. (29 year old man developed multiple hepatic adenomas and hepatocellular carcinoma 12 years after starting oral methyltestosterone for hypopituitarism).
Sale GE, Lerner KG. (1977). Multiple tumors after androgen therapy. Arch Pathol Lab Med. (37 year old man with aplastic anemia developed hepatocellular carcinoma and peliosis hepatis as well as pancreatic and renal tumors after 5 years of anabolic steroid therapy).
Hernandez-Nieto L, Bruguera M, Bombi J, Camacho L, Rozman C. (1977). Benign liver-cell adenoma associated with long-term administration of an androgenic-anabolic steroid (methandienone). Cancer. (19 year old man presented with two hepatic adenomas, one of which ruptured after 3 years of methandienone therapy for paroxysmal nocturnal hemoglobinuria).
Paradinas FJ, Bull TB, Westaby D, Murray-Lyon IM. (1977). Hyperplasia and prolapse of hepatocytes into hepatic veins during longterm methyltestosterone therapy: possible relationships of these changes to the development of peliosis hepatis and liver tumours. Histopathology. (Liver histology from 11 patients treated with methyltestosterone for up to 3 years [ALT abnormal in 6 patients, range 53-246 U/L], found sinusoidal dilatation in most cases and “microcysts” with hyperplasia of hepatocytes that partially occluded the sinusoidal or hepatic vein lumens).
Shapiro P, Ikeda RM, Ruebner BH, Connors MH, Halsted CC, Abildgaard CF. (1977). Multiple hepatic tumors and peliosis hepatis in Fanconi's anemia treated with androgens. Am J Dis Child. (13 year old boy with Fanconi’s anemia, who was treated with oxymetholone for 5-6 years, died of septicemia and was found to have hepatocellular carcinoma and peliosis hepatis on autopsy).
Coombes GB, Reiser J, Paradinas FJ, Burn I. (1978). An androgen-associated hepatic adenoma in a trans-sexual. Br J Surg. (27 year old woman transsexual treated with methyltestosterone for 3 years presented with abdominal pain and was found to have an hepatic adenoma with hemorrhage; no follow up provided).
McDonald EC, Speicher CE. (1978). Peliosis hepatis associated with administration of oxymetholone. JAMA. (26 year old man with Hodgkin’s disease developed jaundice 2 months after starting oxymetholone [bilirubin 6.0 mg/dL, AST ~50 U/L, Alk P ~350 U/L], progressing to liver decompensation and death from sepsis, autopsy showing peliosis hepatis).
Taxy JB. (1978). Peliosis: a morphologic curiosity becomes an iatrogenic problem. Hum Pathol. (Five cases of peliosis hepatis in patients [4 men and 1 woman, ages 35 to 71 years] on anabolic steroids for 3 months to 3 years for cancer or bone marrow disease, several with splenic involvement and one fatal).
Leblay R, Brissot P, leCalve JL, Ferrand B. (1978). Nouv Presse Med.
Benjamin DR, Shunk B. (1978). A fatal case of peliosis of the liver and spleen. Am J Dis Child. (15 year old male with aplastic anemia treated with oxymetholone for 5 years developed sudden intraperitoneal bleeding from splenic peliosis and a capsular tear).
Stromeyer FW, Smith DH, Ishak KG. (1979). Anabolic steroid therapy and intrahepatic cholangiocarcinoma. Cancer. (47 year old man developed an hepatic tumor and progressive hepatic failure 2 years after starting oxymetholone therapy for refractory anemia; autopsy showed cholangiocarcinoma).
Arnold GL, Kaplan MM. (1979). Peliosis hepatis due to oxymetholone—a clinically benign disorder. Am J Gastroenterol. (67 year old man with sideroblastic anemia treated with oxymetholone for 2 years developed jaundice [bilirubin 4.9 mg/dL, ALT 81 U/L, Alk P normal], biopsy showing cholestasis and peliosis, resolving within 2 months of stopping).
Karasawa T, Shikata T, Smith RD. (1979). Peliosis hepatitis: report of nine cases. Acta Pathol Jpn.
Falk H, Thomas LB, Popper H. (1979). Hepatic angiosarcoma associated with androgenic-anabolic steroids. Lancet. (Among 168 cases of angiosarcoma identified in a US retrospective study [1964-74], 4 had received anabolic steroids for 1-23 years).
Scheuer A, Gerdes H, Lehmann FG. (1979). Dtsch Med Wochenschr. (Review of association of anabolic steroids and liver tumors; animal studies suggest that androgens promote liver tumor growth and in humans the association has been best shown in patients with a predisposition to liver cancer [Fanconi’s anemia and chronic hepatitis]).
Treuner J, Niethammer D, Flach A, Fischbach H, Schenck W. (1980). Med Welt. (16 year old boy with aplastic anemia was treated with oxymetholone for 6 years and presented with hepatocellular carcinoma that could not be completely resected but that regressed with stopping androgens).
Montgomery RR, Ducore JM, Githens JH, August CS, Johnson ML. (1980). Regression on oxymetholone-induced hepatic tumors after bone marrow transplantation in aplastic anemia. Transplantation. (13 year old boy with aplastic anemia responded to oxymetholone therapy but developed multiple hepatic tumors 3 years later; underwent bone marrow transplant when aplastic anemia relapsed and over next 3 years liver tumors completely regressed).
Wright JE. (1980). Anabolic steroids and athletics. Exerc Sport Sci Rev. (Review of literature on effects of anabolic steroids on increasing athletic performance as well as side effects).
Pearson K, Zimmerman HJ. (1980). Danazol and liver damage. Lancet. (Five patients, 4 women and 1 man, ages 13 to 34 years, developed abnormal liver tests 1-5 months after starting danazol for endometriosis or angioneurotic edema [ALT 61-126 U/L, AST 81-290 U/L], one had jaundice, but limited details provided).
Saheb F. (1980). Absence of peliosis hepatis in patients receiving testosterone enanthate. Hepatogastroenterology. (Among 52 patients with renal failure who had received testosterone enanthate for anemia, none had peliosis or liver tumors on autopsy, suggesting that natural forms of testosterone do not lead to these complications).
Wilson JD, Griffin JE. (1980). The use and misuse of androgens. Metabolism. (Three types of modifications of testosterone molecule improve its duration of action [β-esterification], improve its oral bioavailability [17α-alkylation], or increase its activity [ring modification]; the 17α-alkylated modifications can cause liver disease).
Pecking A, Lejolly JM, Najean Y. (1980). Nouv Rev Fr Hematol. (254 patients with aplastic anemia were treated with androgens and monitored for up to 8 years; 17% developed jaundice and another 18% had liver test abnormalities without jaundice; no severe liver injury or cirrhosis recorded but 2 developed hepatic adenomas [after 20-21 months]).
Zevin D, Turani H, Cohen A, Levi J. (1981). Androgen-associated hepatoma in a hemodialysis patient. Nephron. (68 year old man on hemodialysis was treated with oxymetholone for 18 months and nandrolone for 18 months when he presented with large hepatic mass, dying two weeks later; hepatocellular carcinoma but no cirrhosis on autopsy).
Cocks JR. (1981). Methyltestosterone-induced liver-cell tumours. Med J Aust. (51 year old man on methyltestosterone for 20 years because of infertility developed hepatic rupture due to hepatocellular carcinoma with regression of mass on stopping androgens).
Ishak KG. (1981). Hepatic lesions caused by anabolic and contraceptive steroids. Semin Liver Dis. (Review of effects of male and female sex hormones on the liver including biochemical changes, subcellular alternations, cholestasis, vascular disorders, hyperplasia, neoplasia and miscellaneous).
Stromeyer FW, Ishak KG. (1981). Nodular transformation (nodular “regenerative hyperplasia”) of the liver: a clinicopathologic study of 30 cases. Hum Pathol. (Analysis of 30 cases of nodular regenerative hyperplasia from the files of the Armed Forces Institute of Pathology; half men, ages 14 to 80 years, variable presentations, 15 died, some of hepatic failure; AST and Alk P mildly elevated; associated diseases included polycythemia vera, rheumatoid arthritis, lymphoproliferative disorders, renal transplantation and autoimmune diseases; associated medications included prednisone, azathioprine, OCCs, and immunosuppressive agents).
Westaby D, Portmann B, Williams R. (1983). Androgen-related primary hepatic tumors in non-Fanconi patients. Cancer. (Three men, ages 28 to 58 years, developed hepatocellular carcinoma after 10-17 years of methyltestosterone therapy for hypogonadism, with some degree of regression upon stopping anabolic steroid).
Turani H, Levi J, Zevin D, Kessler E. (1983). Hepatic lesions in patients on anabolic androgenic therapy. Isr J Med Sci. (11 men on long term androgenic steroids had abnormal liver findings; 3 were found to have carcinoma [hepatocellular and cholangiocarcinoma] and 8 peliosis hepatis).
Cáp J, Ondrus B, Danihel L. (1983). Bratisl Lek Listy.
Malt RA, Galdabini JJ, Jeppsson BW. (1983). Abnormal sex-steroid milieu in young adults with hepatocellular carcinoma. World J Surg. (Among 7 patients ages 20-30 years with hepatocellular carcinoma seen over 15 year period, 2 were men on methyltestosterone in whom the tumor regressed on stopping androgens, and they were alive 2 and 7 years later).
Schmidt E, Deeg HJ, Storb R. (1984). Regression of androgen-related hepatic tumors in patients with Fanconi's anemia following marrow transplantation. Transplantation. (Two patients with Fanconi’s anemia [1 girl, 1 boy] developed liver disease and hepatic masses after being treated with oxymetholone for 4 and 11 years; after bone marrow transplantation the masses regressed as documented by serial imaging studies).
Chandra RS, Kapur SP, Kelleher J, Luban N, Patterson K. (1984). Benign hepatocellular tumors in the young. A clinicopathologic spectrum. Arch Pathol Lab Med. (Seven children with hepatocellular carcinoma without cirrhosis [some had fibrosis] included 4 with aplastic or Fanconi’s anemia who had received oxymetholone for 3 to 8 years; other 3 were found to have cancer incidentally on autopsy, two with thalassemia and one post-renal transplant).
Peces R, Ablanedo P, Alvarez J. (1984). Peliosis hepatis after renal transplantation. Arch Intern Med. (Patient on hemodialysis received androgenic steroids for 2 years developed peliosis hepatis with portal hypertension).
Overly WL, Dankoff JA, Wang BK, Singh ND. (1984). Androgens and hepatocellular carcinoma in an athlete. Ann Intern Med. (26 year old on multiple anabolic steroids for body building for 4 years developed weakness and weight loss and found to have hepatocellular carcinoma).
Lyon J, Bookstein JL, Cartwright CA, Romano A, Heeney DJ. (1984). Peliosis hepatis: diagnosis by magnification wedged hepatic venography. Radiology. (29 year old man with aplastic anemia on oxymetholone for 4 years developed abdominal pain [bilirubin 1.7 mg/dL, ALT 1000 U/L, Alk P 188 U/L], venogram showing changes of peliosis and liver biopsy showing diffuse peliosis and hemorrhage and small adenomas).
Mays ET, Christopherson W. (1984). Hepatic tumors induced by sex steroids. Semin Liver Dis. (Review of experience with 201 benign tumors of liver in women, ages 14 to 57; 98 focal nodular hyperplasia, 2 adenoma and 23 hepatocellular carcinoma, 9 unclassified; oral contraceptive use in 82% regardless of type).
Pelletier G, Frija J, Szekely AM, Clauvel JP. (1984). Adenoma of the liver in man. Gastroenterol Clin Biol. (26 year old man with solitary hepatic adenoma; review of literature found only 31 cases of adenomas in men, 8 of whom had received anabolic steroids).
Zafrani ES, Casier A, Baudelot A-M, Feldmann G. (1984). Ultrastructural lesions of the liver in human peliosis: a report of 12 cases. Am J Pathol. (Electron microscopy of liver biopsies from 12 patients with peliosis, 5 with jaundice, 4 with portal hypertension, ALT elevated in 6, Alk P in 9 and bilirubin in 7: dilation of sinusoids and space of Disse; one case attributed to anabolic steroids).
Goldman B. (1985). Liver carcinoma in an athlete taking anabolic steroids. J Am Osteopath Assoc. (37 year old male athlete taking oxymetholone for 5 years developed 4 pound “malignant tumor”).
McCaughan GW, Bilous MJ, Gallagher ND. (1985). Long-term survival with tumor regression in androgen-induced liver tumors. Cancer. (Two patients with hepatocellular carcinoma arising after 5 and 6 years of therapy with oxymetholone and methyltestosterone had tumor regression on stopping anabolic steroids and survival for more than 10 years).
Lowdell CP, Murray-Lyon IM. (1985). Reversal of liver damage due to long term methyltestosterone and safety of non-17 alpha-alkylated androgens. Br Med J (Clin Res Ed). (1 to 6 year follow up of 42 patients with liver injury from methyltestosterone [Westaby 1977]; all recovered and those on sublingual testosterone had normal liver tests and liver scans).
Nuzzo JL, Manz HJ, Maxted WC. (1985). Peliosis hepatis after long-term androgen therapy. Urology. (After 13 years of testosterone and 16 months of fluoxymesterone replacement therapy, patient presented with jaundice that resolved on reducing dose; on autopsy 5 years later, liver histology showed peliosis).
Buamah PK. (1985). An apparent danazol induced primary hepatocellular carcinoma. J Surg Oncol. (49 year old woman treated with danazol for 2 years for endometriosis presented with jaundice and pain, laparotomy showing hepatocellular carcinoma in noncirrhotic liver).
Carrasco D, Prieto M, Pallardo L, Moll JL, Cruz JM, Monoz C, Berenguer J. (1985). Multiple hepatic adenomas after long-term therapy with testosterone enanthate. J Hepatol. (32 year old man with renal transplant treated with testosterone enanthate for 12 years developed hepatic masses found to be adenomas).
Nesher G, Dolberg L, Zimran A, Hershko A. (1985). Hepatosplenic peliosis after danazol and glucocorticoids for ITP. N Engl J Med. (74 year old woman with immune thrombocytopenia treated with danazol for 3 months was found to have peliosis hepatis during splenectomy).
Nordsten M. (1985). Ugeskr Laeger.
Garrigues Gil V, Berenguer Lapuerta J, Ponce García J, Rayón Martín M. (1986). A non-C17 alkylated steroid and long-term cholestasis. Ann Intern Med. (27 year old woman developed jaundice 4 months after starting 19-norandrostenolone with prolonged jaundice [bilirubin 10.8 m/dL, ALT 310 U/L, Alk P 1560 U/L], lasting 14 months and complete resolution at 21 months).
Serke S, Dienemann D, Speck B, Zimmermann R, Baer U, Huhn D. (1986). Hepatocellular carcinoma and focal nodular hyperplasia associated with norethandrolone-therapy: a case report. Blut. (33 year old woman with aplastic anemia treated with norethandrolone for 4 years presented with abdominal pain and hepatic masses, one being focal nodular hyperplasia and one hepatocellular carcinoma; no follow up given).
Király CL. (1988). Androgen-anabolic steroid effects on serum and skin surface lipids, on red cells, and on liver enzymes. Int J Sports Med.
Boue F, Coffin B, Delfraissy JF. (1986). Danazol and cholestatic hepatitis. Ann Intern Med. (73 year old woman with thrombocytopenic purpura developed pruritus and abnormal liver tests 4 weeks after starting danazol but without jaundice [ALT 57 U/L, peak Alk P 619 U/L], pruritus persisted for 3 weeks, liver test abnormalities for 3 months).
Lucey MR, Moseley RH. (1987). Severe cholestasis associated with methyltestosterone: a case report. Am J Gastroenterol. (62 year old man developed fatigue followed by jaundice 8 months after starting methyltestosterone [bilirubin 29 mg/dL, AST 243 I/L, Alk P 290 U/L], resolving within 2 months of stopping).
Ishak KG, Zimmerman HJ. (1987). Hepatotoxic effects of the anabolic/androgenic steroids. Semin Liver Dis. (Thorough review of the hepatic complications of androgenic steroid use, including cholestasis, peliosis, hyperplastic nodules, nodular regeneration, adenomas, hepatocellular carcinoma and other hepatic malignancies).
Evely RS, Triger DR, Milnes JP, Low-Beer TS, Williams R. (1987). Severe cholestasis associated with stanozolol. Br Med J (Clin Res Ed). (Three patients, ages 62 to 65 years, developed jaundice and pruritus 1-5 months after starting stanozolol [bilirubin 38.6-46.7 mg/dL, AST 56-69 U/L, Alk P 284-732 U/L], resolving 3-6 months after drug withdrawal).
Oda K, Oguma N, Kawano M, Kimura A, Kuramoto A, Tokumo K. (1987). Hepatocellular carcinoma associated with long-term anabolic steroid therapy in two patients with aplastic anemia. Nippon Ketsueki Gakkai Zasshi. (Two patients with aplastic anemia treated with oxymetholone for 12-15 years developed multiple liver tumors and had hepatocellular carcinoma without cirrhosis on autopsy).
Király CL. (1988). Androgenic-anabolic steroid effects on serum and skin surface lipids, on red cells, and on liver enzymes. Int J Sports Med. (Prospective study of 7 power athletes taking multiple anabolic steroids during 6 weeks of training; ALT levels rose [~28 to 52 U/L] and HDL cholesterol levels decreased).
Creagh TM, Rubin A, Evans DJ. (1988). Hepatic tumors induced by anabolic steroids in an athlete. J Clin Pathol. (27 year old male body builder on anabolic steroids for 3 years presented with rupture of large hepatocellular carcinoma).
Lenders JW, Demacker PN, Vos JA, Jansen AJ, Hoitsma AJ. (1988). van ‘t Laar, Thien T. Deleterious effects of anabolic steroids on serum lipoproteins, blood pressure, liver function in amateur body builders. Int J Sports Med. (Among 58 body builders, ALT and AST levels were higher among those currently on anabolic steroids [mean ALT=57 U/L] compared to previous users [36 U/L] and never users [19 U/L], and levels rose during a course of anabolic steroids [29 to 67 U/L]).
Veneri RJ, Gordon SC. (1988). Anabolic steroid-induced cholestasis: choleretic response to corticosteroids. J Clin Gastroenterol. (29 year old male body builder with a history of pruritus and jaundice after starting anabolic steroids developed prolonged pruritus and jaundice 4 months after a one month course of testosterone enanthate injections [bilirubin 16.4 mg/dL, ALT 47 U/L, Alk P 205 U/L], with apparent response to prednisone therapy).
Middleton C, McCaughan GW, Painter DM, Stephen MS, Beale M, Fraser I. (1989). Danazol and hepatic neoplasia: a case report. Aust N Z J Med. (35 year old woman presented with a large hepatocellular carcinoma after several years of intermittent danazol therapy for endometriosis with improvement on stopping danazol and resection).
Winwood PJ, Robertson DA, Wright R. (1990). Bleeding oesophageal varices associated with anabolic steroid use in an athlete. Postgrad Med J. (30 year old male body builder on anabolic steroids for 18 months developed variceal hemorrhage; liver biopsy was read as normal and varices were no longer detected after steroids were stopped).
Gleeson D, Newbould MJ, Taylor P, McMahon RF, Leahy BC, Warnes TW. (1991). Androgen associated hepatocellular carcinoma with an aggressive course. Gut. (48 year old man on methyltestosterone for primary hypogonadism for 24 years presented with abdominal pain and hepatocellular carcinoma; withdrawal of androgens led to regression, but 2 years later he had progressive metastatic disease and died; he was also anti-HCV positive).
Kuipers H, Wijnen J, Hartgen F, Willems S. (1991). Influence of anabolic steroids on body composition, blood pressure, lipid profile and liver function in body builders. Int J Sports Med. (Prospective study of testosterone vs nandrolone vs placebo intramuscular injections for 8 weeks in 50 male and female body builders; androgens led to increase in muscle mass, but also a 25% decrease in HDL cholesterol and increase in diastolic blood pressure; but “all enzyme values remained within the normal range”).
Søe KL, Søe M, Gluud C. (1992). Liver pathology associated with the use of anabolic-androgenic steroids. Liver. (Review of adverse effects of anabolic steroids on the liver with a focus on histologic changes).
Touraine RL, Bertrand Y, Foray P, Gilly J, Philippe N. (1993). Hepatic tumours during androgen therapy in Fanconi anaemia. Eur J Pediatr. (12 year old boy with Fanconi’s anemia developed jaundice after 4.5 years of norethandrolone therapy with three hepatic masses, 4, 8 and 12 cm in size and diagnosed as hepatic adenomas; there was partial resolution on stopping androgen therapy as shown by 50% shrinkage after 16 months).
Cabasso A. (1994). Peliosis hepatis in a young adult bodybuilder. Med Sci Sports Exerc. (27 year old male body builder taking various anabolic steroids for 8 years presented with abdominal pain and hepatic mass compatible with peliosis by CT scan, which regressed on stopping androgens).
Gurakar A, Caraceni P, Fagiuoli S, Van Thiel DH. (1994). Androgenic/anabolic steroid-induced intrahepatic cholestasis: a review with four additional case reports. J Okla State Med Assoc. (4 cases of jaundice due to anabolic steroid use; all men, ages 63, 33, 53 and 26 years, taking anabolic steroids [methyltestosterone, stanozolol or oral testosterone], for 1-5 months, developed jaundice [bilirubin 13.2, 44.3, 47.8, and 19.5 mg/dL, ALT 52, 12, 27 and 33 U/L, Alk P 337, 189, 294, and 137 U/L], with slow resolution 5-12 months after stopping androgens).
Wood P, Yin JA. (1994). Oxymetholone hepatotoxicity enhanced by concomitant use of cyclosporin A in a bone marrow transplant patient. Clin Lab Haematol. (16 year old boy with acute leukemia and bone marrow transplant developed jaundice 2 months after starting oxymetholone [bilirubin 4.0 mg/dL, ALT 488 U/L, Alk P 442 U/L], abnormalities persisting for 3 months after stopping).
Yoshida EM, Karim MA, Shaikh JF, Soos JG, Erb SR. (1994). At what price, glory? Severe cholestasis and acute renal failure in an athlete abusing stanozolol. CMAJ. (26 year old male power lifter developed jaundice one month after starting stanozolol [bilirubin 19.6 rising to 51.2 mg/dL, AST 33 U/L, Alk P 137 U/L], complicated by acute renal failure, biopsy showing intrahepatic cholestasis, resolving slowly over the following 5 months).
Bhasin S, Storer TW, Berman N, Callegari C, Clevenger B, Phillips J, Bunnell TJ, et al. (1996). The effects of supraphysiologic doses of testosterone on muscle size and strength in normal men. N Engl J Med. (Controlled trial of testosterone enanthate vs placebo for 10 weeks in 43 normal men who were also randomized to exercise or not; testosterone increased muscle size and strength; no change in liver enzymes).
Singh C, Bishop P, Wilson R. (1996). Extreme hyperbilirubinemia associated with the use of anabolic steroids, health/nutritional supplements and ethanol: response to ursodeoxycholic acid treatment. Am J Gastroenterol. (24 year old male body builder developed jaundice after 3 month use of several anabolic steroids [stanozolol and nandrolone] and Ma Huang [bilirubin 21 rising to 53 mg/dL, ALT 237 U/L, Alk P 129 U/L], with prolonged jaundice and pruritus resolving 5 months after onset: Case 1).
Staub PG, Leibowitz CB. (1996). Peliosis hepatis associated with oral contraceptive use. Australas Radiol. (35 year old woman on oral contraceptives for several years developed abdominal pain and abnormal imaging studies with multiple lesions of varying size [2-5 cm], biopsy showing peliosis with decrease in size of lesions 6 months after stopping).
Kosaka A, Takahashi H, Yajima Y, Tanaka M, Okamura K, Mizumoto R, Katsuta K. (1996). Hepatocellular carcinoma associated with anabolic steroid therapy: report of a case and review of the Japanese literature. J Gastroenterol. (35 year old woman with aplastic anemia developed hepatocellular carcinoma 3 years after starting oxymetholone therapy, with long term survival after resection and stopping androgens; review of 12 cases reported from Japan).
Mörk H, al-Taie O, Klinge O, Scheurlen M. (1997). Z Gastroenterol. (55 year old man developed jaundice 12 months after starting methyltestosterone [bilirubin 5.1 mg/dL, ALT 177 U/L, Alk P normal]; when bilirubin rose to 8.0 mg/dL, ursodiol was started with resolution in 3 months, whereupon ursodiol was stopped without recurrence).
Dourakis SP, Tolis G. (1998). Sex hormonal preparations and the liver. Eur J Contracept Reprod Health Care. (Review of sex hormones and liver injury; for estrogens complications include cholestasis, cholelithiasis, Budd-Chiari syndrome, peliosis, adenomas and focal nodular hyperplasia and hepatocellular carcinoma; androgenic steroids are not discussed).
Schumacher J, Muller G, Klotz K-F. (1999). Large hepatic hematoma and intraabdominal hemorrhage associated with abuse of anabolic steroids. N Engl J Med. (24 year old male body builder developed hepatic hemorrhage and rupture having used anabolic steroids for 2 years [bilirubin normal, ALT 927 U/L, Alk P normal], biopsy showing extensive hepatic necrosis without malignancy).
Habscheid W, Abele U, Dahm HH. (1999). Dtsch Med Wochenschr. (28 year old male body builder developed jaundice 3 months after starting anabolic steroids [initial bilirubin 4.5 mg/dL, ALT 38 U/L, Alk P 94 U/L], with worsening jaundice and renal failure despite stopping androgens [peak bilirubin 77.9 mg/dL], jaundice lasting 4 months).
Bork K, Pitton M, Harten P, Koch P. (1999). Hepatocellular adenomas in patients taking danazol for hereditary angio-oedema. Lancet. (Among 87 patients with hereditary angioneurotic edema, 41 were treated with danazol, 11 for more than 10 years, 3 of whom developed hepatocellular adenomas at ages 29, 39 and 67 which were resected and did not show carcinoma).
Bagia S, Hewitt PM, Morris DL. (2000). Anabolic steroid-induced hepatic adenomas with spontaneous haemorrhage in a bodybuilder. Aust N Z J Surg. (31 year old male body builder on long term anabolic steroids presented with hemorrhage into a hepatic adenoma ultimately requiring resection).
Simon JA. (2001). Safety of estrogen/androgen regimens. J Reprod Med. (Combinations of estrogen with low doses of methyltestosterone [1.25-2.5 mg] have been used to treat vasomotor symptoms in menopausal women with no serious adverse events, including no hepatic events or liver-enzyme elevations, in 641 women followed prospectively in controlled trials).
Stimac D, Milić S, Dintinjana RD, Kovac D, Ristić S. (2002). Androgenic/Anabolic steroid-induced toxic hepatitis. J Clin Gastroenterol. (26 year old male body builder developed nausea and jaundice 5 weeks after starting anabolic steroids [bilirubin 27.5 mg/dL, ALT 10,580 U/L, Alk P 152 U/L] which he had taken intermittently for 9 years; gradual improvement over 3 months).
Hengge UR, Stocks K, Wiehler H, Faulkner S, Esser S, Lorenz C, Jentzen W, et al. (2003). Double-blind, randomized, placebo-controlled phase III trial of oxymetholone for the treatment of HIV wasting. AIDS. (Controlled trial of 16 weeks of oxymetholone vs placebo is 89 HIV-infected patients; ALT levels rose above 5 times ULN in 31% of oxymetholone, but none of placebo treated patients; one developed jaundice and cholestasis).
Tan RS, Salazar JA. (2004). Risks of testosterone replacement therapy in ageing men. Expert Opin Drug Saf. (Review of use of androgens in aging males for loss of libido and inability to focus mentally; “to our knowledge, there has been no reported hepatotoxicity from testosterone delivered via topical gel, transdermal patch, or by intramuscular injections”).
Orr R, Fiatarone Singh M. (2004). The anabolic androgenic steroid oxandrolone in the treatment of wasting and catabolic disorders: review of efficacy and safety. Drugs. (Review of clinical efficacy and side effects of anabolic steroids and oxandrolone which is approved for use to promote weight gain and decrease catabolism after surgery or severe trauma).
Hartgens F, Kuipers H. (2004). Effects of androgenic-anabolic steroids in athletes. Sports Med. (Review of effects and toxicity of anabolic steroids used to improve athletic performance; “Injectable testosterone cypionate and enanthate preparations do not appear to affect liver function enzymes”).
Velazquez I, Alter BP. (2004). Androgens and liver tumors: Fanconi's anemia and non-Fanconi's conditions. Am J Hematol. (Systematic review of published literature on association of androgen therapy and liver tumors identified 133 cases, 36 in patients with Fanconi’s anemia, others with aplastic anemia, endocrine and gynecological disorders and body builders; most due to oxymetholone, methyltestosterone and danazol, but 6 associated with intramuscular testosterone injections; hepatocellular carcinoma 53%, adenomas 37%, others included cholangiocarcinoma and angiosarcoma).
Maravelias C, Dona A, Stefanidou M, Spiliopoulou C. (2005). Adverse effects of anabolic steroids in athletes. A constant threat. Toxicol Lett. (Review of adverse effects of anabolic steroids in athletes; hepatic effects include serum enzyme elevations, cholestatic jaundice, hepatic tumors and peliosis hepatis).
Socas L, Zumbado M, Pérez-Luzardo O, Ramos A, Pérez C, Hernández J R, Boada L D. (2005). Hepatocellular adenomas associated with anabolic androgenic steroid abuse in bodybuilders: a report of two cases and a review of the literature. Br J Sports Med. (Two cases of hepatic adenomas in male body builders abusing anabolic steroids; ages 35 and 23 years old on anabolic steroids for 6 months and 15 years presented with hepatic masses which appeared to be benign and regressed on stopping anabolic steroids).
Capra F, Nicolini N, Morana G, Guglielmi A, Capelli P, Vantini I. (2005). Vanishing bile duct syndrome and inflammatory pseudotumor associated with a case of anabolic steroid abuse. Dig Dis Sci. (32 year old treated for 3 years with testosterone undecanoate for hypogonadism developed jaundice [bilirubin 37 mg/dL, ALT 182 U/L, Alk P 212 U/L], with inflammatory pseudo tumor and biopsy showing paucity of bile ducts, although patient ultimately recovered).
Clark BM, Schofield RS. (2005). Dilated cardiomyopathy and acute liver injury associated with combined use of ephedra, gamma-hydroxybutyrate, and anabolic steroids. Pharmacotherapy. (40 year old man developed shortness of breath and jaundice starting 2 months after initiating therapy with androgens and ephedra to promote muscle development [bilirubin 3.9 mg/dL, ALT 2173 U/L, Alk P normal], requiring therapy for congestive cardiomyopathy, but ultimately recovering over next 18 months).
Jasiurkowski B, Raj J, Wisinger D, Carlson R, Zou L, Nadir A. (2006). Cholestatic jaundice and IgA nephropathy induced by OTC muscle building agent Superdrol. Am J Gastroenterol. (23 year old body builder developed abdominal pain and jaundice two months after starting an over-the-counter supplement called “Superdrol” [containing methasteron] [bilirubin 36.2 mg/dL, ALT 93 U/L, Alk P 224 U/L], with protracted jaundice and itching and biopsy showing marked cholestasis with minimal inflammation).
Kafrouni MI, Anders RA, Verma S. (2007). Hepatotoxicity associated with dietary supplements containing anabolic steroids. Clin Gastroenterol Hepatol. (Two cases; 31 and 40 year old body builders developed prolonged jaundice and pruritus beginning 4 and 6 weeks after starting “Superdrol” [bilirubin 37.5 and 49.7 mg/dL, ALT 59 and 301 U/L, Alk P 375 and 416 U/L], with slow recovery over ensuing 2-3 months).
McCullough MC, Namias N, Schulman C, Gomez E, Manning R, Goldberg S, Pizano L, et al. (2007). Incidence of hepatic dysfunction is equivalent in burn patients receiving oxandrolone and controls. J Burn Care Res. (Retrospective analysis of liver test results during oxandrolone therapy of patients with major burns; some evidence of hepatic dysfunction found in 43% of oxandrolone and 43% of 61 control subjects).
Patil JJ, O'Donohoe B, Loyden CF, Shanahan D. (2007). Near-fatal spontaneous hepatic rupture associated with anabolic androgenic steroid use: a case report. Br J Sports Med. (43 year old professional body builder developed abdominal pain and hepatic rupture having used anabolic steroids for 25 years; cause of rupture not explained [peliosis vs adenoma vs carcinoma]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al., Drug Induced Liver Injury Network(DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, at least 6 were due to anabolic steroids being used for body building or for improving athletic performance, but none were attributed to physician-prescribed androgenic steroids).
Sánchez-Osorio M, Duarte-Rojo A, Martínez-Benítez B, Torre A, Uribe M. (2008). Anabolic-androgenic steroids and liver injury. Liver Int. (29 year old man developed progressive fatigue, nausea and then jaundice and pruritis 2-3 months after starting high dose anabolic steroids [bilirubin 29 mg/dL, ALT 54 U/L, Alk P 694 U/L], jaundice persisting for 2 months, but resolving completely by 5 months after stopping).
Gorayski P, Thompson CH, Subhash HS, Thomas AC. (2008). Hepatocellular carcinoma associated with recreational anabolic steroid use. Br J Sports Med. (35 year old male body builder presented with large hepatocellular carcinoma having used anabolic steroids for several years [bilirubin 0.6 mg/dL, ALT 364 U/L, Alk P 70 U/L, alpha-fetoprotein normal], no follow up provided).
Martin NM, Abu Dayyeh BK, Chung RT. (2008). Anabolic steroid abuse causing recurrent hepatic adenomas and hemorrhage. World J Gastroenterol. (27 year old male body builder having used anabolic steroids for 5 years had spontaneous hepatic bleeding from 10 cm hepatic adenoma [bilirubin 2.2 mg/dL, ALT 2457 U/L, Alk P 275 U/L], treated with resection and had recurrence 3 years later having restarted anabolic steroid use).
Shah NL, Zacharias I, Khettry U, Afdhal N, Gordon FD. (2008). Methasteron-associated cholestatic liver injury: clinicopathologic findings in 5 cases. Clin Gastroenterol Hepatol. (5 cases of jaundice due to methasteron use by male body builders, ages 20 to 33 years, with onset of symptoms 1-2 months after starting the nutritional supplement [initial bilirubin 7.6-41.8 mg/dL, ALT 59-151 U/L, Alk P 85-189 U/L], all resolving with stopping the 17-alkylated androgenic steroid).
Singh V, Rudraraju M, Carey EJ, Byrne TJ, Vargas HE, Williams JE, Balan V, et al. (2009). Severe hepatotoxicity caused by a methasteron-containing performance-enhancing supplement. J Clin Gastroenterol. (3 men, ages 25, 33, and 51, developed jaundice and pruritus 1-2 months after starting "Superdrol", a form of methasteron [bilirubin 8.3, 17.3 and 22 mg/dL, ALT 69, 236 and 1025 U/L, Alk P 106, 111 and unknown U/L] associated with hepatic encephalopathy and peak INR 1.5, in one patient, but resolving spontaneously in all within 6-12 weeks of onset).
Nasr J, Ahmad J. (2009). Severe cholestasis and renal failure associated with the use of the designer steroid Superdrol (methasteron): a case report and literature review. Dig Dis Sci. (42 year old man developed jaundice and pruritus 7 weeks after starting "Superdrol" with methasteron [bilirubin 41.2 mg/dL, ALT 98 U/L, Alk P 353 U/L, creatinine 3.5 mg/dL], both renal and liver injury resolving slowly over the following 4 months).
Choi SK, Jin JS, Cho SG, Choi SJ, Kim CS, Choe YM, Lee KY. (2009). Spontaneous liver rupture in a patient with peliosis hepatis: a case report. World J Gastroenterol. (20 year old man with aplastic anemia treated with oxymetholone for 8 years developed spontaneous rupture of liver due to peliosis hepatis, responding to hemi-hepatectomy and stopping androgenic steroids).
Bispo M, Valente A, Maldonado R, Palma R, Glória H, Nóbrega J, Alexandrino P. (2009). Anabolic steroid-induced cardiomyopathy underlying acute liver failure in a young bodybuilder. World J Gastroenterol. (40 year old body builder developed fatigue followed by jaundice having used large doses of anabolic steroids for 10 years [bilirubin 6.8 mg/dL, ALT 7125 U/L, INR 3.3, LDH 7140 U/L], acute liver failure being due to ischemic hepatitis caused by cardiomyopathy, responding rapidly to treatment of right heart failure).
Masumori N, Ikeda H, Endo T. (2009). Acute hepatitis induced by replacement oral testosterone product in a female-to-male patient with gender identity disorder. Int J Urol. (27 year old female-to-male transgender woman developed fatigue 3 months after switching from fluoxymesterone to methyltestosterone [both oral 17-alpha methylated androgenic steroids] [bilirubin 1.2 mg/dL, peak ALT 1418 U/L, Alk P not given], resolving within 6 weeks of stopping).
Krishnan PV, Feng ZZ, Gordon SC. (2009). Prolonged intrahepatic cholestasis and renal failure secondary to anabolic androgenic steroid-enriched dietary supplements. J Clin Gastroenterol. (Three cases of anabolic steroid induced hepatotoxicity; 21, 30 and 38 year old men developed jaundice and pruritus 4 to 8 weeks after starting a nutritional supplement with an oral anabolic steroid [bilirubin 8.0-53 mg/dL, ALT 200-467 U/L, Alk P 104-494 U/L], with slow recovery after stopping).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to anabolic steroid use).
Woerdeman J, de Hon O, Levi M, de Ronde WP. (2010). Ned Tijdschr Geneeskd. (Review of anabolic steroid use in the Netherlands and their complications including cholestasis).
Wingert N, Tavakoli H, Yoder E. (2010). Acute hepatitis and personality change in a 31-year-old man taking prohormone supplement SUS500. Psychosomatics. (31 year man developed fatigue and personality change having used an prohormone nutritional supplement for one year [ALT 1754 U/L, bilirubin and Alk P not given], resolving rapidly after stopping the supplement).
van Amsterdam J, Opperhuizen A, Hartgens F. (2010). Adverse health effects of anabolic-androgenic steroids. Regul Toxicol Pharmacol. (Review of the health consequences of anabolic steroid use including cholestasis, hepatic adenoma and peliosis).
Büttner A, Thieme D. (2010). Side effects of anabolic androgenic steroids: pathological findings and structure-activity relationships. Handb Exp Pharmacol. (Review of the side effects of anabolic steroids based upon structure-activity relationships).
Tornai I. (2010). Orv Hetil. (Review of risk factors for hepatocellular carcinoma mentions that oral contraceptives may play a role in some cases).
Schwingel PA, Cotrim HP, Salles BR, Almeida CE, dos Santos CR, Nachef B, Andrade AR, et al. (2011). Anabolic-androgenic steroids: a possible new risk factor of toxicant-associated fatty liver disease. Liver Int. (Among 180 recreational body builders, mean aminotransferase levels were higher [ALT: 43 vs 31 U/L and AST: 55 vs 32 U/L] and more likely to be elevated [33% vs 7%] in those who admitted to use of injectable anabolic steroids, who were also more likely to have steatosis by ultrasound evaluation).
Machado MV, Cortez-Pinto H. (2011). The dark side of sports: using steroids may harm your liver. Liver Int. (Editorial in response to Schwingel [2011]).
Yurci A, Yucesoy M, Unluhizarci K, Torun E, Gursoy S, Baskol M, Guven K, Ozbakir O. (2011). Effects of testosterone gel treatment in hypogonadal men with liver cirrhosis. Clin Res Hepatol Gastroenterol. (Among 10 hypogonadal men with cirrhosis treated with transdermal testosterone, there was no change in ALT or bilirubin and none developed clinically apparent liver injury).
Rosenfeld GA, Chang A, Poulin M, Kwan P, Yoshida E. (2011). Cholestatic jaundice, acute kidney injury and acute pancreatitis secondary to the recreational use of methandrostenolone: a case report. J Med Case Rep. (50 year old man with chronic hepatitis C developed anorexia, weight loss and jaundice 8 weeks after starting methandrostenolone [bilirubin 53.9 mg/dL, ALT 56 U/L, Alk P 154 U/L] accompanied by mild pancreatitis and renal insufficiency, resolving slowly after stopping anabolic steroids).
Neri M, Bello S, Bonsignore A, Cantatore S, Riezzo I, Turillazzi E, Fineschi V. (2011). Anabolic androgenic steroids abuse and liver toxicity. Mini Rev Med Chem. (Review of the hepatic complications of anabolic steroid use).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon herbalife and hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids).
Avelar-Escobar G, Méndez-Navarro J, Ortiz-Olvera NX, Castellanos G, Ramos R, Gallardo-Cabrera VE, Vargas-Alemán Jde J, et al. (2012). Hepatotoxicity associated with dietary energy supplements: use and abuse by young athletes. Ann Hepatol. (17 year old boy developed jaundice and pruritus 3 months after starting dietary supplements [N.O.Xplode, Growth Factor ATN and SimiCaritina] for body building [bilirubin 17.5 rising to 31.5 mg/dL, ALT 640 U/L, Alk P 850 U/L, GGT normal], with resolution within 6-8 weeks of stopping).
Kou T, Watanabe M, Yazumi S. (2012). Hepatic failure during anabolic steroid therapy. Gastroenterology. (78 year old man developed jaundice and fatigue 2 years after starting danazol for thrombocytopenic purpura [bilirubin 11.7 mg/dL, ALT 185 U/L, Alk P 677 U/L] and died 26 days later, autopsy showing peliosis hepatis).
Timcheh-Hariri A, Balali-Mood M, Aryan E, Sadeghi M, Riahi-Zanjani B. (2012). Toxic hepatitis in a group of 20 male body-builders taking dietary supplements. Food Chem Toxicol. (20 male body builders, ages 24 to 32 years, presented with jaundice and pruritus having been taking 3 supplements for a year [bilirubin 3.9-8.0 mg/dL, ALT 225-600 U/L, Alk P 325-701 U/L], the responsible agent causing the injury being unclear from the list of ingredients).
Elsharkawy AM, McPherson S, Masson S, Burt AD, Dawson RT, Hudson M. (2012). Cholestasis secondary to anabolic steroid use in young men. BMJ. (Two cases, 16 and 32 year old men developed jaundice and pruritus 5 days and 2 months after starting an anabolic steroid "methandrostenolone" [bilirubin 25.8 and 38.0 mg/dL, ALT 156 and 76 U/L, Alk P 203 and 262 U/L], requiring 4 months to resolve after stopping).
Elsharkawy AM, McPherson S, Masson S, Burt A, Dawson RT, Hudson M. [Cholestasis in young men after taking anabolic steroids]. Praxis (Bern 1994) 2012; 101: 661-4. German. (Same cases as described by the authors in BMJ [2012]).
Porro LJ, Herndon DN, Rodriguez NA, Jennings K, Klein GL, Mlcak RP, Meyer WJ, et al. (2012). Five-year outcomes after oxandrolone administration in severely burned children: a randomized clinical trial of safety and efficacy. J Am Coll Surg. (Among children with severe burns, 70 received oxandrolone for one year and 152 served as standard of care controls; ALT levels were elevated to a similar degree in both groups during the acute period, returning to normal levels 3-6 months after the burns).
Pais-Costa SR, Lima OA, Soares AF. (2012). Giant hepatic adenoma associated with anabolic-androgenic steroid abuse: case report. Arq Bras Cir Dig. (28 year old male body builder developed abdominal pain having been on anabolic steroids for 6 years, surgery revealing two hepatic adenomas, one being 10 cm in diameter).
Vilella AL, Limsuwat C, Williams DR, Seifert CF. (2013). Cholestatic jaundice as a result of combination designer supplement ingestion. Ann Pharmacother. (50 year old man developed jaundice and pruritus 2 months after starting body building supplements [bilirubin 29.4 mg/dL, ALT 125 U/L, Alk P 160 U/L], with slow recovery upon stopping).
El Sherrif Y, Potts JR, Howard MR, Barnardo A, Cairns S, Knisely AS, Verma S. (2013). Hepatotoxicity from anabolic androgenic steroids marketed as dietary supplements: contribution from ATP8B1/ABCB11 mutations?. Liver Int. (Two men, ages 25 and 45 years, developed jaundice 3 and 6 weeks after starting an anabolic steroid "Mass-Drol" [bilirubin 10.8 and 6.0 mg/dL, ALT 207 and 152 U/L, Alk P 137 and 259 U/L, GGT 72 and 59 U/L = normal], sequencing of ABC B11 [the gene that is abnormal in FIC1] was normal).
Hymel BM, Victor DW, Alvarez L, Shores NJ, Balart LA. (2013). Mastabol induced acute cholestasis: A case report. World J Hepatol. (26 year old man developed jaundice and pruritus 10 days after starting daily injections of the anabolic steroid "Mastabol" [peak bilirubin 23.6 mg/dL, ALT 117 U/L, Alk P 441 U/L], improving slowly on withdrawal).
Archer JR, Dargan PI, Hudson S, Wood DM. (2013). Analysis of anonymous pooled urine from portable urinals in central London confirms the significant use of novel psychoactive substances. QJM. (Analysis of pooled urine samples collected from 12 public urinals in central London identified cocaine, cannabis and MDMA from 11 sites, amphetamines from 10 and anabolic steroids from 4).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 due to herbals and dietary supplements, including one each attributed to Dianabol [methandrostenolone], "Mega men heart" and "Serious Mass").
Supasyndh O, Satirapoj B, Aramwit P, Viroonudomphol D, Chaiprasert A, Thanachatwej V, Vanichakarn S, et al. (2013). Effect of oral anabolic steroid on muscle strength and muscle growth in hemodialysis patients. Clin J Am Soc Nephrol. (Among 43 hemodialysis patients treated with oxymetholone or placebo for 24 weeks, fat free mass and handgrip strength increased with the androgenic steroid, but liver enzymes rose from a mean serum ALT of 15 to 70 U/L and direct bilirubin from 0.09 to 0.51 mg/dL and one patient stopped therapy early because of “cholestatic hepatitis”).
Hoedebecke K, Rerucha C, Maxwell K, Butler J. (2013). Drug-induced liver injury secondary to testosterone prohormone dietary supplement use. J Spec Oper Med. (28 year old Special Services member developed pruritus and jaundice 4 weeks after starting a testosterone prohormone supplement [bilirubin 13.6 mg/dL rising to 27.2 ten days later, ALT 693 U/L, Alk P not given], with slow recovery).
Ding NS, De Cruz P, Lim L, Thompson A, Desmond P. (2013). Androgenic-anabolic steroid drug-induced liver injury. Intern Med J. (46 year old man took two anabolic steroids for two months and developed jaundice several months later [bilirubin 17.8 mg/dL, ALT 125 U/L, Alk P 295 U/L, GGT 114 U/L], resolving on no therapy within 7 weeks).
Bauman WA, Spungen AM, Collins JF, Raisch DW, Ho C, Deitrick GA, Nemchausky BA, et al. (2013). The effect of oxandrolone on the healing of chronic pressure ulcers in persons with spinal cord injury: a randomized trial. Ann Intern Med. (Among 41 patients with pressure ulcers treated with oxandrolone or placebo for 24 weeks, ulcer healing was not affected but asymptomatic ALT elevations arose in 32% on androgenic steroids vs 2.9% on placebo, and 4.6% of patients stopped therapy early because of liver test abnormalities, all of which resolved within 4 weeks of stopping).
Luciano RL, Castano E, Moeckel G, Perazella MA. (2014). Bile acid nephropathy in a bodybuilder abusing an anabolic androgenic steroid. Am J Kidney Dis. (41 year old man developed weight loss, pruritus and jaundice 6 weeks after starting nandrolone twice weekly, testosterone once weekly and daily methandrostenolone [bilirubin 11.8 rising to 47.9 mg/dL, ALT 267 U/L, Alk P 162 U/L], with worsening renal function [creatinine rising to 2.9 mg/dL] but ultimate full recovery).
Awai HI, Yu EL, Ellis LS, Schwimmer JB. (2014). Liver toxicity of anabolic androgenic steroid use in an adolescent with nonalcoholic fatty liver disease. J Pediatr Gastroenterol Nutr. (18 year old male with history of NASH developed jaundice 2 weeks after starting “Beastrdrol” [bilirubin 11 rising to 28 mg/dL, ALT 229 U/L, GGT 65 U/L], resolving within 3 months of stopping).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, only one was attributed to an androgenic steroid [nandrolone]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 185 were attributed to HDS but only 31 [3.5%] to anabolic steroids).
Abbate V, Kicman AT, Evans-Brown M, McVeigh J, Cowan DA, Wilson C, Coles SJ, et al. (2015). Anabolic steroids detected in bodybuilding dietary supplements - a significant risk to public health. Drug Test Anal. (24 products sold at fitness store were analyzed and 23 were found to have anabolic steroids, with 16 different than package label and one without steroids. Of 13 different anabolic steroids identified, 12 were controlled substance emphasizing the availability of anabolic steroids in herbal supplements).
Robles-Diaz M, Gonzalez-Jimenez A, Medina-Caliz I, Stephens C, García-Cortes M, García-Muñoz B, Ortega-Alonso A, et al. (2015). Spanish DILI Registry; SLatinDILI Network. Distinct phenotype of hepatotoxicity associated with illicit use of anabolic androgenic steroids. Aliment Pharmacol Ther. (Combination of Spanish and Latin American databases included 25 cases of anabolic steroid jaundice [8% of cases from 2010-2013], all men, mean age 32 [bilirubin 12 times, ALT 14 times, and Alk P 1.3 times ULN], renal dysfunction developing in 6 [24%] all with bilirubin levels above 35 mg/dL, but ultimate recovery in all and no mortality).
Schwingel PA, Cotrim HP, Santos CR, Santos AO, Andrade AR, Carruego MV, Zoppi CC. (2015). Recreational anabolic-androgenic steroid use associated with liver injuries among Brazilian young men. Subst Use Misuse. (Among 923 Brazilian recreational body builders, 182 [20%] admitted to anabolic steroid use [long term but often intermittent], of whom 38.5% had elevated liver enzymes and 12% had hepatic steatosis by ultrasound; one had focal nodular hyperplasia and one a hepatic adenoma but none evidently had jaundice or clinically apparent liver injury).
Brazeau MJ, Castaneda JL, Huitron SS, Wang J. (2015). A case report of supplement-induced hepatitis in an active duty service member. Mil Med. (26 year old Army soldier developed jaundice 4 months after starting “Mutant Plexx” for body building being unaware that it contained anabolic steroids [bilirubin 4.9 mg/dL, ALT 223 U/L], resolving within 3 months of stopping).
Tabatabaee SM, Elahi R, Savaj S. (2015). Bile cast nephropathy due to cholestatic jaundice after using stanozolol in 2 amateur bodybuilders. Iran J Kidney Dis. (Two men, ages 30 and 43 years, developed jaundice and renal dysfunction 3 and 6 weeks after starting oral and parenteral stanozolol [bilirubin 48 and 49 mg/dL, ALT 33 and 66 U/L, Alk P 535 and 690 U/L, creatinine 8.7 and 1.9 mg/dL], both ultimately requiring dialysis but eventually recovering).
Flores A, Nustas R, Nguyen HL, Rahimi RS. (2016). Severe cholestasis and bile acid nephropathy from anabolic steroids successfully treated with plasmapheresis. ACG Case Rep J. (31 year old man developed jaundice 16 weeks after starting a regimen that included 2 anabolic steroids [bilirubin 53 mg/dL] with severe pruritus, weight loss, hepatic encephalopathy and renal dysfunction treated with plasmapheresis with subsequent improvement).
Bourgeois AL, Auriche P, Palmaro A, Montastruc JL, Bagheri H. (2016). Risk of hormonotherapy in transgender people: Literature review and data from the French Database of Pharmacovigilance. Ann Endocrinol (Paris). (Review of the literature and adverse event registries on medical regimens for transgender individuals, trans-males receiving antiestrogens [GnRH analogues and antigonadotropins] and testosterone, which can be associated with serum enzyme elevations but has not been linked to clinically apparent liver injury).
Alkhunaizi AM, ElTigani MA, Rabah RS, Nasr SH. (2016). Acute bile nephropathy secondary to anabolic steroids. Clin Nephrol. (28 year old man developed jaundice 6 months after starting a body building regimen that included several anabolic steroids [bilirubin 5.6 rising to 44 mg/dL, ALT and Alk P not provided], with accompanying bilirubin nephropathy and bile stained urinary granular casts and renal tubular epithelial cells).
Bond P, Llewellyn W, Van Mol P. (2016). Anabolic androgenic steroid-induced hepatotoxicity. Med Hypotheses. (Hypothesis suggesting that potent engagement of the androgen receptor by synthetic anabolic steroids would up-regulate carnitine palmitoyltransferase 1 [CPT1], which controls mitochondrial fatty acid β-oxidation and would result in generation of reactive oxygen species that would damage hepatocytes).
Magee CD, Witte S, Kwok RM, Deuster PA. (2016). Mission compromised? drug-induced liver injury from prohormone supplements containing anabolic-androgenic steroids in two deployed U.S. service members. Mil Med. (Two actively deployed service members developed liver injury 3-4 weeks after starting combinations of products said to be prohormone supplements [one with jaundice and one with serum ALT elevations], and testing of the products [“TANK”, “DMZ” and “Epi-10”] revealed several anabolic steroids including stanozolol, methyltestosterone and methasteron among others).
Cabb E, Baltar S, Powers DW, Mohan K, Martinez A, Pitts E. (2016). The diagnosis and manifestations of liver injury secondary to off-label androgenic anabolic steroid use. Case Rep Gastroenterol. (45 year old man developed jaundice and pruritus 3 months after starting two anabolic steroids [bilirubin 4.9 rising to 6.4 mg/dL, ALT 102 U/L, Alk P 262 U/L], resolving in follow up).
Boks MN, Tiebosch AT, van der Waaij LA. (2017). A jaundiced bodybuilder; cholestatic hepatitis as side effect of injectable anabolic-androgenic steroids. J Sports Sci. (24 year old man developed pruritus and jaundice several weeks after finishing an 8 week cycle of trenbolone enanthate, a C-19 and C-17β substituted androgenic steroid used in cattle and used by body builders under the popular name “Tren”, [bilirubin 9.3 rising to 31.5 mg/dL, ALT 115 U/L, Alk P 70 U/L, GGT 36 U/L], worsening for 6 weeks but ultimately resolving).
Solimini R, Rotolo MC, Mastrobattista L, Mortali C, Minutillo A, Pichini S, Pacifici R, et al. (2017). Hepatotoxicity associated with illicit use of anabolic androgenic steroids in doping. Eur Rev Med Pharmacol Sci. (Review of the mechanism of action of androgenic steroids and their synthetic derivatives, usually with either 17-α alkylation, which creates an orally available, anabolic product that is capable of causing cholestasis, or 17-β esterification that creates an hydrophobic and long acting form of testosterone and is not likely to cause cholestasis).
Velho I, Fighera TM, Ziegelmann PK, Spritzer PM. (2017). Effects of testosterone therapy on BMI, blood pressure, and laboratory profile of transgender men: a systematic review. Andrology.
Eapen J, Ayoola R, Subramanian RM. (2018). 'The efficacy of extracorporeal liver support with molecular adsorbent recirculating system in severe drug-induced liver injury'. Oxf Med Case Reports. (Systematic review of the literature on studies of adverse effects of testosterone [parenteral undecanoate, cypionate, enanthate, propionate or topical gel or patch] therapy for transgender men identified six studies that included tests of liver function which changed minimally or not at all, no levels rising above the upper limits of normal for men).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al. (2018). Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of drug induced liver injury enrolled in a Spanish registry between 1994 and 2016, 32 [3.7%] were due to HDS products and another 20 [2.3%] to anabolic steroids; only in men, mean age 31 years, 95% with jaundice, none fatal, and mean bilirubin 17 times, ALT 14 times, GGT 1.8 times and Alk P 1.3 times ULN).
Hassan A, Fontana RJ. (2018). Liver injury associated with sporting activities. Semin Liver Dis. (Review of liver injury associated with athletic activities discusses heat stroke, anabolic steroid jaundice and HDS induced liver injury from body building supplements).
Kiracofe B, Coffey R, Jones LM, Bailey JK, Thomas S, Porter K, Murphy CV. (2019). Incidence of oxandrolone induced hepatic transaminitis in patients with burn injury. Burns. (Among 66 patients hospitalized for significant body burns treated with oxandrolone with frequent monitoring, 28 [42%] developed elevations in ALT or AST, but abnormalities were asymptomatic and transient and there was no mention of clinically apparent liver injury).
Stolz A, Navarro V, Hayashi PH, Fontana RJ, Barnhart HX, Gu J, Chalasani NP, et al. (2019). DILIN Investigators. Severe and protracted cholestasis in 44 young men taking bodybuilding supplements: assessment of genetic, clinical and chemical risk factors. Aliment Pharmacol Ther. (Among 44 patients with anabolic steroid jaundice enrolled in a prospective database between 2004 and 2013, all were men, aged 21 to 59 years presenting with jaundice an average of 2.5 months after starting the steroid [bilirubin 9.8 rising to 25.8 mg/dL, ALT 169 U/L, Alk P 111 U/L], jaundice persisting for an average of 3 months, but ultimately resolving with no mortality or liver transplantation; various rare and function affecting variants in the bile acid transporter genes were found but none consistently).
Zheng E, Sandhu N, Navarro V. (2020). Drug-induced liver injury secondary to herbal and dietary supplements. Clin Liver Dis. (Review of HDS associated liver injury including that caused by anabolic steroids which has increase in the last 2 decades both in US and European registries, the typical case marked by intense and prolonged cholestasis arising 1-4 months after starting an anabolic steroid, rarely fatal, liver histology showing marked canalicular cholestasis with minimal inflammation and necrosis, referred to as bland cholestasis).
Petrov PD, Fernández-Murga L, Conde I, Martínez-Sena T, Guzmán C, Castell JV, Jover R. (2020). Epistane, an anabolic steroid used for recreational purposes, causes cholestasis with elevated levels of cholic acid conjugates, by upregulating bile acid synthesis (CYP8B1) and cross-talking with nuclear receptors in human hepatocytes. Arch Toxicol. (Among 3 patients with bland cholestasis due to epistane, all had marked increases in serum bile acids, largely primary conjugated forms; while in vitro studies demonstrated that epistane increases bile acid synthesis in hepatocytes, with no change in SHP and decrease in FGF-19 with accompanying increases in bile acid synthetic genes and increases in transporters; epistane also activates the androgen receptor and increases bile acid levels via CYP8B1).
Flores JE, Chitturi S, Walker S. (2020). Drug-induced liver injury by selective androgenic receptor modulators. Hepatol Commun. (Two patients, 24 and 49 year old men, developed jaundice 10 weeks and 4 months after starting over-the-counter selective androgen receptor modulators [SARMs] called Ligandrol and RAD-140 for body building [bilirubin 6.8 and 17.1 mg/dL, ALT 273 and 54 U/L, Alk P 289 and 327 U/L], resolving in follow up at 4 and 12 months after stopping the products).

## OTHER REFERENCE LINKS

1 Recent References on Anabolic Steroids: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Androgenic+Steroids+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Anabolic Steroids: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Androgenic)